# Delandistrogene Moxeparvovec

## OVERVIEW

### Introduction

Delandistrogene Moxeparvovec (Elevidys) is an adeno-associated virus (AAV) vector-based gene therapy developed for Duchenne muscular dystrophy. The AAV-based gene therapy is given as a single, one-time infusion and is often followed by transient elevations in serum aminotransferase levels and has also been linked to uncommon instances of clinically apparent acute liver injury that can be severe and even fatal.

### Background

Delandistrogene Moxeparvovec (Elevidys) is an adeno-associated virus (AAV) vector based gene therapy developed for treatment of Duchenne muscular dystrophy (DMD). DMD is an X-linked genetic disorder marked by an absence or deficiency in functional dystrophin that causes a progressive neuromuscular disorder. The lack of a functional dystrophin protein leads to damage to muscles during contraction that results in replacement of normal muscle by fibrosis tissue and fat. Children with DMD usually become progressively weaker in infancy, non-ambulatory in the early teens, require mechanical ventilation by the age of 20, and die from cardiac or respiratory failure 5 to 20 years thereafter. Current therapy includes corticosteroids that delay loss of muscle function and several recently approved antisense molecules that are partially effective in patients with specific dystrophin mutations in exons 45, 51, and 53; eteplirsen (approved in 2016), golodiresen (2019), viltolarsen (2020), and casimersen (2021). Delandistrogene moxeparvovec is a non-replicating adeno-associated virus that contains a synthetic DNA that encodes a micro-dystrophin protein, a shortened but functional form of the large and complex dystrophin protein. In several clinical trials of single infusions of delandistrogene moxeparvovec in ambulatory 4 to 8 year old children with DMD, the microdystrophin protein was detected in skeletal muscle when measured at 12 weeks. In short-term follow-up, there was significant differences in ambulatory rating scores between recipients and placebo controls who were 4 or 5 years for age, but not in those 6 or 7 years of age. Furthermore, preliminary studies in older children and in non-ambulatory patients showed presence of the micro-dystrophin after treatment with delandistrogene moxeparvovec but only a trend in evidence of clinical benefit. In 2023, delandistrogene moxeparvovec was given accelerated approval in the United States for ambulatory children ages 4 and 5 years. These indications were expanded to full approval for ambulatory patients 4 years of age or older and to accelerated approval for non-ambulatory patients above the age of 4 years. These approvals were based primarily on micro-dystrophin expression in muscle tissue and to trends in changes in measures of muscle function. Therapy is restricted to patients with a confirmed mutation in the DMD gene and no or only low titers of pre-existing anti-AAV antibody. Therapy is given as a single intravenous infusion of 1.33 x10^14^ vector genomes per kilogram body weight. Delandistrogene moxeparvovec is available in solution in single use vials under the brand name Elevidys. Corticosteroids should be administered for the first 60 days beginning a day before the gene therapy infusion. Adverse events include anorexia, nausea and vomiting, fever, thrombocytopenia, serum aminotransferase elevations, and infusion reactions. Uncommon but potentially serious adverse events include severe hypersensitivity reactions and anaphylaxis, immune-mediated myositis and myocarditis, and clinically apparent acute liver injury that can be fatal. Within 2 years of its approval, a temporary clinical hold was placed on delandistrogene moxeparvovec because of reports of acute liver failure in two non-ambulatory recipients. The hold was subsequently lifted.

### Hepatotoxicity

In a pre-registration, small, controlled trial, liver test abnormalities occurred in 41% of 63 children with DMD treated with delandistrogene moxeparvovec compared to 8% of 62 controls. However, the enzyme elevations were transient and only mild to moderate in severity (less than 5 times the upper limit of normal or of baseline). In open label studies, more marked enzyme elevations arose in 3 subjects, but none developed jaundice or evidence of significant hepatic dysfunction, and all resolved without residual effects either spontaneously or with additional corticosteroid therapy. All patients received corticosteroids at the time of the gene therapy infusion, which was continued to 60 days, which probably ameliorated the course of liver injury in these pre-registration trials. For these reasons, the product label recommended monitoring of routine liver tests before therapy and weekly for the first 3 months after the infusion. After approval of delandistrogene moxeparvovec and its clinical use both in the United States and abroad, at least 2 cases of severe acute hepatitis resulting in fatalities were reported which led to a temporary hold on its use. The clinical features of these cases have yet to be published, but all 2 cases were in non-ambulatory patients. Thus, hepatitis injury including clinically apparent liver injury with acute liver failure can occur with this AAV-vector based gene therapy.

Likelihood score: C (probable cause of clinically apparent liver injury including acute liver failure and death).

### Mechanism of Injury

The mechanism by which delandistrogene moxeparvovec causes liver injury is unclear and under ongoing evaluation. The injury may be due to an immune response to AAV antigens or dystrophin protein expressed in the liver.

### Outcome and Management

The serum aminotransferase elevations that occur after infusions of delandistrogene moxeparvovec for DMD are usually mild to moderate in severity and can resolve spontaneously but often require adjustment of corticosteroid therapy and sometimes are followed by clinically apparent hepatitis and severe injury. The product label has a warning regarding liver injury and recommends routine monitoring of liver tests before therapy and weekly for at least 3 months and until results are unremarkable. Interpretation of liver test abnormalities is complicated by the frequency of pre-existing elevations in serum CPK, AST, and ALT due to the muscle injury from DMD. For this reason, monitoring would best include GGT or other liver specific enzymes. Corticosteroid therapy is warranted if serious acute liver injury is suspected.

Drug Class: Genetic Disease Agents

Duchenne Muscular Dystrophy Agents:

Other Drugs in the Subclass: Casimersen (https://www.ncbi.nlm.nih.gov/books/n/livertox/Casimersen/), Eteplirsen (https://www.ncbi.nlm.nih.gov/books/n/livertox/Eteplirsen/), Golodirsen (https://www.ncbi.nlm.nih.gov/books/n/livertox/Golodirsen/), Viltolarsen (https://www.ncbi.nlm.nih.gov/books/n/livertox/Viltolarsen/)

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Delandistrogene moxeparvovec – Elevidys®

DRUG CLASS

Genetic Disorder Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Elevidys)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Elevidys | D12633 | Not available

## ANNOTATED BIBLIOGRAPHY

References updated: 10 August 2025

Abbreviations Used: DMD, Duchenne muscular dystrophy; AAV, adeno-associated virus

https://www.fda.gov/vaccines-blood-biologics/tissue-tissue-products/elevidys (FDA website with information on delandistrogene moxeparvovec [Elevidys] including product labels, FDA letters and safety alerts, and the integrated clinical review of data submitted in support of its approval by the sponsor which has extensive information on safety and liver adverse events).
Hoy SM. Delandistrogene moxeparvovec: first approval. Drugs. 2023;83:1323-1329. [underlined: PMID][underlined: :]. (Review of the mechanism of action, history of development, pharmacodynamics, clinical efficacy, and safety of delandistrogene moxeparvovec shortly after its approval for use in the United States, mentions that it “demonstrated a consistent and manageable safety profile” and that serious adverse events included vomiting, increased transaminase levels, rhabdomyolysis, and liver injury). 37566211
Delandistrogene moxeparvovec (Elevidys) for Duchenne muscular dystrophy. Med Lett Drugs Ther. 2023;65(1686):159-160. PMID:. (Concise review of the mechanism of action, clinical efficacy, safety, and costs of delandistrogene moxeparvovec shortly after its accelerated approval in the United States mentions that serious liver injury can occur and patients require monitoring before and weekly for the first 3 months). 37755693
Zaidman CM, Proud CM, McDonald CM, Lehman KJ, Goedeker NL, Mason S, Murphy AP, et al. Delandistrogene Moxeparvovec gene therapy in ambulatory patients (aged ≥4 to &lt;8 years) with Duchenne muscular dystrophy: 1-year interim results from study SRP-9001-103 (ENDEAVOR). Ann Neurol. 2023;94:955-968.. (Among 20 boys aged 4 to 8 years treated with delandistrogene moxeparvovec, increased microdystrophin expression in muscle biopsies was detected at week 12 and adverse events included vomiting [55%], anorexia [45%] and liver enzyme elevations [40%], one patient requiring hospital admission and intravenous corticosteroids, resolving in 2 months). 37539981
Mendell JR, Sahenk Z, Lehman KJ, Lowes LP, Reash NF, Iammarino MA, Alfano LN, et al. Long-term safety and functional outcomes of delandistrogene moxeparvovec gene therapy in patients with Duchenne muscular dystrophy: A phase 1/2a nonrandomized trial. Muscle Nerve. 2024;69:93-98.. (Among 4 ambulatory boys with DMD [ages 4 to 8 years] treated with delandistrogene moxeparvovec and followed for 4 years, adverse events were frequent [including liver enzyme elevations in all 4] but generally arose with in the first 70 days and resolved by the first year with no late liver enzyme elevations). 37577753
Horn S, Fehse B. Wie sicher ist die Gentherapie? : Zweiter Todesfall nach Therapie der Duchenne-Muskeldystrophie [How safe is gene therapy? : Second death after Duchenne therapy]. Inn Med (Heidelb). 2024;65:617-623. German. PMID: 38748280. (Review of the literature on safety and efficacy of AAV-based vectors used in gene therapies of DMD including delandistrogene moxeparvovec, mentions reports of 2 deaths of acute liver failure after AAV-vector based gene therapies as a reason for caution in its use).
In brief: Expanded indication for Elevidys. Med Lett Drugs Ther. 2024;66(1709):135-136.. (Summary of changes in approval of delandistrogene moxeparvovec in 2024 to full approval in ambulatory patients with DMD who are 4 years or older and accelerated approval for use in non-ambulatory patients; no mention of hepatic adverse events). 39137177
Bhattacharyya M, Miller LE, Miller AL, Bhattacharyya R. The FDA approval of delandistrogene moxeparvovec-rokl for Duchenne muscular dystrophy: a critical examination of the evidence and regulatory process. Expert Opin Biol Ther. 2024;24:869-871.. (Discussion of controversy surrounding approval of delandistrogene moxeparvovec by the FDA which was based upon a short-term surrogate marker and minor improvements in muscle function that did not reach statistical significance, rather than hard endpoints of a significant increase in muscle function and lack of disease progression). 39152743
Mendell JR, Muntoni F, McDonald CM, Mercuri EM, Ciafaloi E, Komaki H, Leon- Astudillo C, et al. AAV gene therapy for Duchenne muscular dystrophy: the EMBARK phase 3 randomized trial. Nat Med. 2025;31:332-341.. (Among 125 boys aged 4 to 8 with DMD treated with delandistrogene moxeparvovec or placebo and followed for 52 weeks, key function endpoints occurred equally in the two groups although there was marked micro-dystrophin expression in the treated group [34% vs 0%] and a trend for improvement in some measures of function, while severe adverse events occurred in 22% vs 8% and liver enzyme elevations arose in 41% of treated patients including ‘hepatotoxicity” in one patient [ALT 1868 U/L, GGT 107 U/L, bilirubin 2.3 rising to 6.5 mg/dL] requiring high doses of corticosteroids). 39385046
Duvuru R, Neumann S, Beemarajan E, Burnette WB, Cox R, Mohammad S, Modi AJ, et al. Acute liver injury following delandistrogene moxeparvovec gene therapy requiring intravenous immunoglobulin. Pediatr Neurol. 2025;163:1-3.. (Two boys, 4 and 5 year old, with DMD developed liver injury 5 to 6 weeks after a single infusion of delandistrogene moxeparvovec with asymptomatic increases in ALT and AST above baseline and distinct increases in GGT [from normal to 221 U/L and 71 U/L initially and peaking at 378 and 283 U/L] lasting for months despite increased corticosteroids, ultimately requiring intravenous immune globulin). 39615430
Jolly H, Aartsma-Rus A, Bertini E, De Waele L, Haberlova J, Klein A, Niks E, et al. Gene therapy approval for Duchenne muscular dystrophy: a European perspective. Lancet. 2025;405(10489): 1572-1573.. (A cautionary letter on the decision by the FDA to give accelerated approval for delandistrogene moxeparvovec for DMD based upon the surrogate marker of microdystrophin expression in muscle and not evidence for improved muscle function or stabilization of the disease progression which may require larger trials with longer follow up). 40318867

## OTHER REFERENCE LINKS

1. Recent References on Delandistrogene moxeparvovec: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(delandistrogene%20moxeparvovec)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Delandistrogene moxeparvovec: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=delandistrogene%20moxeparvovec)